# Prazosin

## OVERVIEW

### Introduction

Prazosin is a nonselective alpha-adrenergic antagonist (alpha-blocker) used in the therapy of hypertension. Prazosin is associated with a low rate of transient serum aminotransferase elevations and has not been clearly linked to clinically apparent acute liver injury.

### Background

Prazosin (pray' zoe sin) was the first alpha-adrenergic antagonist to be approved for use in the United States and is still widely used for therapy of hypertension. Prazosin inhibits alpha-adrenergic receptors present on smooth muscle in arterioles (so-called alpha-1b adrenergic receptors) as well as in those in the bladder neck and prostate (alpha-1a adrenergic receptors). The inhibition of alpha-adrenergic tone in blood vessels causes relaxation of arteriolar resistance and lowering of the blood pressure. Prazosin was approved for use in the United States in 1976 and is still used for treatment of hypertension, although rarely as a first line agent and usually in combination with other antihypertensives. Prazosin has not been fully evaluated or approved for therapy of benign prostatic hypertrophy (as have other alpha-1 adrenergic antagonists). Prazosin is available in capsules of 1, 2 and 5 mg generically and under the trade name Minipress. Prazosin is usually started at a dose of 1 mg two or three times daily, with increase in the dose based upon tolerance and clinical response to an average of 5 to 20 mg daily in divided doses. Prazosin is also available in a fixed combination with polythiazide (Minizide). Side effects include dizziness and syncope (particularly with the initial dose), fatigue, headache, palpitations, impotence, incontinence and gastrointestinal upset. Rare, but potentially severe side effects include severe postural hypotension and priapism.

### Hepatotoxicity

Prazosin has been associated with a low rate of serum aminotransferase elevations that in controlled trials was no higher than with placebo therapy. These elevations were transient and did not require dose modification. No instances of clinically apparent acute liver injury due to prazosin have been published in the literature, but reports of cholestatic hepatitis have been received by the sponsor. Among the alpha adrenergic receptor antagonists, the most frequently implicated agent in causing liver injury has been alfuzosin with only single, and not well documented cases linked to other alpha blockers. Thus, acute symptomatic liver injury due to prazosin is quite rare, and severe hepatotoxicity must be exceeding rare, if it occurs at all.

Likelihood score: E* (unproven but suspected rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the minor serum aminotransferase elevations associated with prazosin is not known. Prazosin is extensively metabolized by the liver and generation of a mildly toxic intermediate is a possible explanation.

References on the safety and potential hepatotoxicity of prazosin and other alpha-blockers are given in the Overview on Alpha-1 Adrenergic Receptor Antagonists.

Drug Class: Antihypertensive Agents

Other Drugs in the Subclass, Alpha-1 Adrenergic Receptor Antagonists: Doxazosin, Terazosin

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Prazosin – Generic, Minipress®

DRUG CLASS

Antihypertensive Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=prazosin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Prazosin | 19216-56-9 | C19-H21-N5-O4 | Prazosin Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Prazosin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Prazosin/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Prazosin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Prazosin)